# Flavocoxid

## OVERVIEW

### Introduction

Flavocoxid is a medical food consisting of plant derived flavonoids which have antiinflammatory activity and are used to treat chronic osteoarthritis. Flavocoxid has been linked to minor elevations in serum enzyme levels during therapy and to rare instances of clinically apparent liver injury.

### Background

Flavocoxid (flay" voe kox' id) is a proprietary blend of purified plant derived bioflavonoids including baicalin and catechins. Flavocoxid inhibits cyclooxygenases (both Cox-1 and Cox-2) as well as lipoxygenases (5-Lox) in vitro and in animal models, which may account for its antiinflammatory and antioxidant activity. Flavocoxid inhibits the conversion of arachidonic acid to reactive prostaglandins and reduces the levels of these inflammatory mediators in synovial fluid. Flavocoxid was approved for use as a medical food in the United States in 2004. However, this approval was withdrawn in December 2017 and it is not longer available as an FDA approved medical food. It was previously available by prescription for use in chronic osteoarthritis in tablets of 500 mg under the commercial name Limbrel. The typical dose was 500 mg twice daily. Side effects were not common and were similar in frequency to those experienced by patients on placebo.

### Hepatotoxicity

In premarketing clinical trials, serum aminotransferase elevations occurred in up to 10% of patients on flavocoxid therapy, but elevations above 3 times the upper limit of normal occurred in only 1% to 2% of recipients. Since its release, however, there have been several reports of clinically apparent acute liver injury attributed to flavocoxid. Most cases have occurred in women, who perhaps are more likely to use flavocoxid. The time to onset was 1 to 5 months, and the pattern of enzyme elevations was usually hepatocellular or mixed. Most cases were moderate in severity and no instance of acute liver failure or death has been reported. Resolution upon stopping flavocoxid occurred in 1 to 3 months. Immunoallergic features were present in some patients, but were mild and autoantibodies were not common. At least one instance of recurrence upon rechallenge has been reported.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Flavocoxid is a proprietary mixture of plants and herbs and it is unclear which component(s) might be responsible for liver injury. The mixture includes extracts from Scutellaria baicalensis (skullcap, containing the phytochemical baicalin) and Acacia catechu (catechin), both of which have been implicated in causing rare instances of idiosyncratic acute liver injury, but the mechanism is unknown.

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been linked to flavocoxid use and all cases have been self-limited, without subsequent chronic hepatitis or vanishing bile duct syndrome. Recurrence upon reexposure has been reported and rechallenge should be avoided. There is no information on possible cross sensitivity of hepatic injury with other medications or herbal agents such as skull cap or green tea.

Drug Class: Herbal and Dietary Supplements; Antirheumatic Agents

## CASE REPORT

### Case 1. Acute hepatitis with jaundice after flavocoxid therapy.

[Modified from Case 1: Chalasani N, Vuppalanchi R, Navarro V, Fontana R, Bonkovsky H, Barnhart H, Kleiner DE, Hoofnagle JH. Acute liver injury due to flavocoxid (Limbrel), a medical food for osteoarthritis: a case series. Ann Intern Med 2012; 156: 857-60, W297-300. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/22711078)]

A 58 year old woman developed jaundice 10 weeks after starting flavocoxid (500 mg twice daily) for osteoarthritis. She had no history of liver disease, risk factors for viral hepatitis and did not drink alcohol. Other medications included aspirin, tramadol, omeprazole, ezetimibe, zolpidem, glucosamine, calcium, flaxseed oil and vitamins, all of which she had taken chronically. Physical examination was largely unremarkable, but her laboratory tests showed elevations in serum bilirubin (2.5 mg/dL), ALT (1105 U/L), AST (1198 U/L) and alkaline phosphatase (487 U/L) (Table). There was no eosinophilia and the prothrombin time was normal. Liver tests had been normal on several occasions in the past. Flavocoxid was discontinued, but over the next week she became jaundiced (peak bilirubin 7.3 mg/dL) and serum enzyme levels remained elevated. Tests for hepatitis A, B, C and E were negative as were autoantibodies. Ultrasound of the abdomen showed no evidence of biliary obstruction or hepatic masses. A liver biopsy showed a moderately severe, acute lobular hepatitis with portal inflammation (including eosinophils) without evidence of chronic liver disease or fibrosis. Two weeks after stopping flavocoxid she began to improve. Symptoms resolved within a month and all liver tests were normal when she was seen 3 months after onset. Flavocoxid was not restarted.

#### Key Points

Medication: | Flavocoxid (500 mg twice daily)
Pattern: | Hepatocellular (R=5.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 months
Recovery: | 3 months
Other medications: | Aspirin, tramadol, omeprazole, ezetimibe, zolpidem, glucosamine, calcium, flaxseed oil and vitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 23 | 109 | 0.6
3 months | 0 | 1105 | 487 | 2.5 | Admission
| 4 days | 1259 | 530 | 3.4
| 10 days | 1540 | 525 | 7.3 | Liver biopsy
| 16 days | 1195 | 433 | 3.9
4 months | 26 days | 431 | 218 | 2.1
| 30 days | 298 | 215 | 1.3 | Asymptomatic
| 5 weeks | 97 | 151 | 0.8
5 months | 6 weeks | 42 | 124 | 0.8
6 months | 12 weeks | 11 | 117 | 0.5
9 months | 24 weeks | 14 | 89 | 0.2
Normal Values | | <42 | <105 | <1.2

#### Comment

A 58 year old woman suffered a moderate case of acute liver injury with a hepatocellular pattern of serum enzyme elevations arising after three months of flavocoxid therapy. A liver biopsy suggested drug induced liver injury, and no other obvious cause of acute hepatitis was identified. The serum ALT and AST were in the typical range for acute viral hepatitis, but the prominent elevation in alkaline phosphatase suggested a somewhat “mixed” pattern, which is more typical of drug induced liver injury. Flavocoxid is a medical food and regulated more as a nutritional supplement than a drug. Medical foods can be prescribed for specific indications (such as osteoarthritis), but have not undergone the rigorous proof of efficacy and safety that are required of medications. They are "generally recognized as safe" by the FDA. Flavocoxid, however, has recently been withdrawn, more likely due to questions of efficacy rather than safety.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flavocoxid – Limbrel®

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Flavocoxid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Baicalin | 21967-41-9 | C21-H18-O11 | Baicalin Chemical Structure
Catechin | 154-23-4 | C15-H14-O6 | Catechin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999, discusses hepatotoxicity of NSAIDs, but does not specifically mention flavocoxid).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs; flavocoxid is not mentioned).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to flavocoxid). 18955056
Morgan SL, Baggott JE, Moreland L, Desmond R, Kendrach AC. The safety of flavocoxid, a medical food, in the dietary management of knee osteoarthritis. J Med Food 2009; 12: 1143-8. (Among 59 patients with osteoarthritis treated with placebo or flavocoxid for 12 weeks, side effects were mild and similar to placebo, with no overall differences in serum aminotransferase levels). 19857081
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to flavocoxid). 20949552
Levy RM, Khokhlov A, Kopenkin S, Bart B, Ermolova T, Kantemirova R, Mazurov V, et al. Efficacy and safety of flavocoxid, a novel therapeutic, compared with naproxen: a randomized multicenter controlled trial in subjects with osteoarthritis of the knee. Adv Ther 2010; 27: 731-42. (Controlled trial of 12 week course of flavocoxid versus naproxen in 220 patients with osteoarthritis found similar rates of ALT elevations, and no patient had clinically apparent hepatitis or an ALT level >5 times ULN). 20845002
Pillai L, Burnett BP, Levy RM; GOAL Study Cooperative Group. GOAL: multicenter, open-label, post-marketing study of flavocoxid, a novel dual pathway inhibitor anti-inflammatory agent of botanical origin. Curr Med Res Opin 2010; 26: 1055-63. (Among 1005 patients with osteoarthritis treated with flavocoxid in an open label study, liver test abnormalities occurred in only one [0.1%], but no details given). 20225990
Levy RM. Flavocoxid and hypersensitivity pneumonitis. Chest 2011; 140: 827-8; author reply 828. (Letter mentions that among an estimated 270,000 persons treated with flavocoxid since its marketing in 2004, 3 cases of drug induced hypersensitivity pneumonitis were reported to the sponsor). 21896531
Product information. Limbrel. 2011. (The product sponsor mentions that liver test abnormalities were found in less than 10% of patients treated with flavocoxid, but that levels of 3-5 times ULN occurred in less than 2% and that there were rare instances of hepatitis [n=3] and jaundice [n=6] that were self-limited and resolved rapidly with stopping).
Chalasani N, Vuppalanchi R, Navarro V, Fontana R, Bonkovsky H, Barnhart H, Kleiner DE, Hoofnagle JH. Acute liver injury due to flavocoxid(Limbrel), a medical food for osteoarthritis: a case series. Ann Intern Med 2012; 156: 857-60, W297-300. (Four women, ages 57 to 68 years, developed jaundice 1-3 months after starting flavocoxid [peak bilirubin 2.0 to 20.8 mg/dL, ALT 741 to 1540 U/L, Alk P 286 to 770 U/L], resolving in 1 to 3 months: Case 1). 22711078
Reichenbach S, Jüni P. Medical food and food supplements: not always as safe as generally assumed. Ann Intern Med 2012; 156: 894-5, W314. (Editorial in response to Chalasani [2012] discussing the potential of herbals and medical foods for causing adverse events and the need for better regulation and monitoring of their use). 22711083
https://www.fda.gov/safety/recalls/ucm594357.htm (News report on the voluntary nationwide recall of flavocoxid due to rare, but serious adverse events including liver enzyme elevations and hepatitis).

## OTHER REFERENCE LINKS

1. Recent References on Flavocoxid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Flavocoxid+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Flavocoxid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Flavocoxid)